# Levofloxacin

## OVERVIEW

### Introduction

Levofloxacin is a third generation fluoroquinolone that is widely used in the treatment of mild-to-moderate respiratory and urinary tract infections due to sensitive organisms. Levofloxacin has been linked to rare instances of clinically apparent hepatic injury marked by a short latency period and a hepatocellular pattern of enzyme elevations, similar to what has been described with ciprofloxacin.

### Background

Levofloxacin (lee" voe flox' a sin) is the L-enantiomer of ofloxacin and is considered a third generation fluoroquinolone. Like other fluoroquinolones, levofloxacin is active against a wide range of aerobic gram-positive and gram-negative organisms. The fluoroquinolones are believed to act by inhibition of type II DNA toposiomerases (gyrases) that are required for synthesis of bacterial mRNAs (transcription) and DNA replication. They demonstrate little inhibition of human, host enzymes and have had an excellent safety record. Levofloxacin was approved for use in the United States in 1996 and remains in wide use. Levofloxacin is used for mild-to-moderate infections, the typical indications including sinusitis, bronchitis, community acquired pneumonia, skin infections, urinary tract infections, pyelonephritis, prostatitis, plague and anthrax. Levofloxacin is available in generically and under the commercial name Levaquin as tablets of 250, 500 and 750 mg, the usual dose being 250 to 750 mg once daily depending upon the indication and severity of the infection. Intravenous formulations are available for moderate-to-severe infections, the usual IV dosages being 500 mg daily. Oral therapy is typically continued for 7 to 14 days, but both shorter and longer courses have been used. Levofloxacin, like other fluoroquinolones, is generally well tolerated, but common side effects can include gastrointestinal disturbances, headaches, skin rash and allergic reactions. Rare, but more severe side effects include QT prolongation, seizures, hallucinations, tendon rupture, severe hypersensitivity reactions, Stevens Johnson syndrome, angioedema and photosensitivity.

### Hepatotoxicity

In short term studies, levofloxacin has been associated with minor elevations in serum ALT and AST levels in 2% to 5% of patients. The abnormalities were usually asymptomatic and transient and rarely require dose modification. With its wide scale use, levofloxacin has been implicated in in at least 50 instances of clinically apparent liver injury mostly in isolated case reports. The clinical presentation and course are typical of the hepatotoxicity of other fluoroquinolones, and the injury is likely a class effect. The latency to onset is usually short (1 to 3 weeks) and the onset is often abrupt with a hepatocellular or mixed pattern of injury, jaundice and, in some instances, hepatic failure. Cholestatic hepatitis can also occur. Immunoallergic features such as fever, rash and eosinophilia are common, but not particularly prominent. Autoantibodies are rare. The liver injury is usually self-limited, but several cases of acute liver failure have been linked to fluoroquinolones as well as instances of prolonged jaundice, cholestasis and vanishing bile duct syndrome. Levofloxacin, like ciprofloxacin, has also been implicated hypersensitivity reactions including rare cases of Stevens Johnson syndrome and toxic epidermal necrolysis, which may be accompanied by liver injury. While liver injury from levofloxacin is rare, the fluoroquinolones collectively are among the most frequent causes of clinically apparent liver injury including fatal cases and cases of chronic liver injury and bile duct paucity.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The rapid onset and severe course of levofloxacin associated liver injury suggests hypersensitivity, although allergic manifestations are not always present and are generally mild and transient.

### Outcome and Management

The severity of levofloxacin liver injury ranges from mild and transient serum enzyme elevations to self-limited hepatocellular injury, cholestatic hepatitis, to acute liver failure. In milder cases, complete recovery is expected after stopping the drug and resolution of clinical symptoms and signs is usually rapid (4 to 8 weeks). There are no known effective therapies for levofloxacin or other fluoroquinolone associated liver injury. Features of hypersensitivity, such as fever and rash may respond rapidly to corticosteroids, but the dose and duration of such treatment should be limited and carefully monitored. Recurrence of features of hypersensitivity and liver injury on rechallenge is common and should be avoided. Cross reactivity of the hepatic injury between different fluoroquinolones has been demonstrated in rare instances and, based upon the similarity of clinical patterns of injury and latency, should be suspected. Thus, patients should be advised to avoid further exposure to levofloxacin as well as other fluoroquinolones.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Fluoroquinolones: Ciprofloxacin, Delafloxacin, Gemifloxacin, Moxifloxacin, Norfloxacin, Ofloxacin

## CASE REPORT

### Case 1. Acute hepatocellular injury due to levofloxacin therapy.(1)

A 74 year old woman with emphysema and chronic atrial fibrillation was admitted for therapy of suspected acute bronchitis and treated with intravenous methylprednisolone (60 mg/day) and levofloxacin (500 mg/day). Serum aminotransferases were normal on admission, but became abnormal after 3 days of therapy and were markedly elevated by 5 days (Table). She became mildly icteric, but recovered rapidly once levofloxacin was discontinued. There was no rash or eosinophilia. Tests for hepatitis A, B and C were negative and ultrasonography of the liver and biliary tract was normal. She had no history of alcohol use and there was no apparent episode of acute heart failure or shock. While she appeared to be recovering from the hepatic injury, she developed progressive pulmonary failure, pneumonia and died of sepsis, gastrointestinal bleedings and multiorgan failure several weeks later.

#### Key Points

Medication: | Levofloxacin, 500 mg intravenously daily for 5 days
Pattern: | Hepatocellular (ALT elevations with normal Alk P)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 5 days
Recovery: | Incomplete before death due to complications of underlying illness
Other medications: | Digoxin, coumadin, inhaled albuterol and ipratropium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1 day | | 40 | 82 | 0.4 | Protime 15 sec.
3 days | | 128 | 89 | 0.5
5 days | 0 | 7071 | 73 | 1.9 | Protime 37 sec.
7 days | 2 days | 3736 | 70 | 2.5
8 days | 3 days | 2336 | 81 | 1.7
9 days | 4 days | 1659 | 85 | 1.2
10 days | 5 days | 749 | 85 | 1.2
16 days | 11 days | 75 | 90 | 0.8
Normal Values | | <53 | <115 | <1.2

#### Comment

This patient developed dramatic serum aminotransferase elevations within days of starting levofloxacin, compatible with the short latency period and abrupt onset of hepatic injury that is typical of liver injury from the fluoroquinolones. In this instance, another possible diagnosis was acute heart failure and ischemic hepatitis, but no mention was made in the brief report of hypotension or hypoxemia. Serum LDH levels would have been helpful in making this distinction. The patient did not develop rash, fever or eosinophilia with the hepatic injury, but she was receiving high doses of methylprednisolone which may have blunted these manifestations of hypersensitivity (as well as the severity of the liver injury itself). While recovering from the hepatic injury, the patient developed further pulmonary complications and died of multiorgan failure. Thus, while apparently self-limited, the hepatic injury may have contributed to her further complications of her chronic obstructive pulmonary disease.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levofloxacin – Generic, Levaquin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=levofloxacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Levofloxacin | 100986-85-4 | C18-H20-F-N3-O4

## CITED REFERENCE

1 Karim A, Ahmed S, Rossoff LJ, Siddiqui RK, Steinberg HN. (2001). Possible levofloxacin-induced acute hepatocellular injury in a patient with chronic obstructive lung disease. Clin Infect Dis.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2020

Zimmerman HJ. Quinolones. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p 603. (Expert review of hepatotoxicity published in 1999; mentions that cinoxacin, nalidixic acid, ciprofloxacin, norfloxacin, enoxacin, and ofloxacin are associated with minor serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury; levofloxacin is not discussed).
Moseley RH. Fluoroquinolones. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 468-9. (Review of hepatotoxicity of fluoroquinolones; mentions that hepatocellular and cholestatic forms of injury have been reported due to the quinolones including cases of ductopenia, acute liver failure and death).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-22. (Textbook of pharmacology and therapeutics).
Kahn JB. (2001). Latest industry information on the safety profile of levofloxacin in the United States. Chemotherapy. (Industry summary of postmarketing reporting on adverse side effects of levofloxacin; after 130 million prescriptions, estimated rate of hepatitis and hepatic failure was less than 1 per million prescriptions).
Spahr L, Rubbia-Brandt L, Marinescu O, Armenian B, Hadengue A. (2001). Acute fatal hepatitis related to levofloxacin. J Hepatol. (99 year old man developed jaundice 8 days after starting oral levofloxacin [bilirubin 18.9 mg/dL, ALT 4440 U/L, Alk P 157 U/L, prothrombin time 57 seconds], with rapid progression to coma and death 6 days after presentation).
Karim A, Ahmed S, Rossoff LJ, Siddiqui RK, Steinberg HN. (2001). Possible levofloxacin-induced acute hepatocellular injury in a patient with chronic obstructive lung disease. Clin Infect Dis. (74 year old woman developed serum enzyme elevations within 2 days and jaundice after 5 days of iv levofloxacin [bilirubin 2.5 mg/dL, ALT 4962 U/L, Alk P 90 U/L], with rapid improvement upon stopping; however, patient subsequently died of sepsis and multiple organ failure: Case 1).
Digwood-Lettieri S, Reilly KJ, Haith LR, Patton ML, Guilday RJ, Cawley MJ, Ackerman BH. (2002). Levofloxacin-induced toxic epidermal necrolysis in an elderly patient. Pharmacotherapy. (78 year old woman developed rash 2 days after finishing a 10 day course of levofloxacin, with blistering and mucosal sloughing involving 73% of body surface area and stormy course but recovery; no mention of liver test results).
Heluwaert F, Roblin X, Duffournet V, Capony P, Martin D, Roblin X. (2003). Rev Med Interne. (31 year old woman developed jaundice a few days after a 5 day course of oral levofloxacin [bilirubin 8.1, ALT 9.6 times ULN, Alk P 1.9 times ULN], with persistence of jaundice and pruritus for 1 month, but resolution within 2 months).
Schwalm JD, Lee CH. (2003). Acute hepatitis associated with oral levofloxacin therapy in a hemodialysis patient. CMAJ. (73 year old man with diabetes, coronary artery disease and renal failure was found to be jaundiced and confused 3 weeks after starting oral levofloxacin [bilirubin 4.1 mg/dL, ALT 857 U/L, Alk P 423 U/L, INR 2.4], improving rapidly upon stopping levofloxacin, but dying 2 weeks later from postoperative complications after bilateral above knee amputations).
Coban S, Ceydilek B, Ekiz F, Erden E, Soykan I. (2005). Levofloxacin-induced acute fulminant hepatic failure in a patient with chronic hepatitis B infection. Ann Pharmacother. (55 year old woman, who was known to be an HBsAg carrier, developed jaundice and fatigue 2 days after finishing a 2 week course of oral levofloxacin [bilirubin 32.3 mg/dL, ALT 401 U/L, Alk P 147 U/L, prothrombin time 29.7 seconds], developing hepatic failure and dying 3 months later, becoming HBsAg negative with injury but remaining IgM anti-HBc negative).
Carrascosa MF, Lucena MI, Andrade RJ, Caviedes JRS, et al. (2009). Fatal acute hepatitis after sequential treatment with levofloxacin, doxycycline, and naproxen in a patient presenting with acute Mycoplasma pneumoniae infection. Clin Ther. (63 year old man developed jaundice 6 days after stopping a 4 day course of levofloxacin and at the end of a 6 day course of doxycycline [bilirubin 4.0 mg/dL, ALT 1577 U/L, Alk P 189 U/L], progressing to hepatic failure and death 17 days later).
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH, DILIN Research Group. (2011). Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol. (Among 679 cases of drug induced liver injury presenting between 2004 and 2010 at 8 US medical centers, 12 [1.8%] were attributed to fluoroquinolones including 6 cipro-, 4 moxi-, 1 levo-, and 1 gatifloxacin; average time to onset 4 days [range 1-39], with both hepatocellular and cholestatic enzyme patterns, seven with rash or fever, mortality limited to those with hepatocellular injury and jaundice; levofloxacin case was 23 year old woman who developed mixed serum enzyme elevations [peak bilirubin 0.8 mg/dL, ALT 199 U/L, Alk P 170 U/L] 1 day after starting drug).
Figueira-Coelho J, Pereira O, Picado B, Mendonça P, Neves-Costa J, Neta J. (2010). Acute hepatitis associated with the use of levofloxacin. Clin Ther. (77 year old man with chronic bronchitis developed liver test elevations within 7 days of starting levofloxacin [peak bilirubin 0.7 mg/dL, ALT 912 U/L, Alk P 119 U/L], improving upon stopping and resolving completely within 3 months).
García-Aparicio J, Herrero-Herrero JI. (2010). Farm Hosp. (65 year old woman received TMP/SMZ for 5 days, followed by levofloxacin for 6 days and then doxycycline for 10 days with sertraline for the whole period, developing fatigue and pruritus 15 days after stopping antibiotics [bilirubin 3.5 rising to 14.2 mg/dL, ALT 937 U/L, Alk P 373 U/L], resolving with stopping all medications and prednisone therapy).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 1 was attributed to ciprofloxacin, but none to other fluoroquinolones including levofloxacin).
Titos-Arcos JC, Hallal H, Robles M, Andrade RJ. (2011). Gastroenterol Hepatol. (51 year old woman developed serum enzyme elevations within 5 days of starting oral levofloxacin and iv ceftriaxone [bilirubin normal, ALT 41 U/L, Alk P 1327 U/L], resolving within a month of stopping both antibiotics).
Coelho J, Gonçalves C, Leitão S, Marques Dos Santos R, Nascimento Costa J. (2011). Acta Med Port. (Two cases of levofloxacin hepatotoxicity in elderly patients [81 and 87 years old] with type 2 diabetes, with onset of symptoms or jaundice within 3 weeks of starting [bilirubin 2.2 and 7.8 mg/dL, ALT 85 and 352 U/L, Alk P 1129 and 908 U/L], both with recovery after stopping).
(2011). Levofloxacin revisited. Med Lett Drugs Ther. (Short review of the safety of levofloxacin stressing the adverse effects of tendon rupture, hypersensitivity reactions, Stevens Johnson syndrome and toxic epidermal necrolysis).
Fernández Arenas O, López Lunar E, Gutiérrez García M, Hidalgo Correas FJ, García Díaz B. (2012). Farm Hosp. (84 year old woman developed rash within a day of starting levofloxacin that was continued for 4 days, and followed a week later by extensive rash with mucosal involvement and complicated course; no mention of hepatic injury).
Paterson JM, Mamdani MM, Manno M, Juurlink DN, Canadian Drug Safety and Effectiveness Research Network. (2012). Fluoroquinolone therapy and idiosyncratic acute liver injury: a population-based study. CMAJ. (In a population based study using Canadian health care databases, the risk of admission to hospital for acute liver injury was increased for persons who received a prescription for moxifloxacin or levofloxacin relative to clarithromycin, but not for ciprofloxacin).
Hayashi PH, Chalasani NP. (2012). Liver injury in the elderly due to fluoroquinolones: should these drugs be avoided?. CMAJ. (Editorial in response to Paterson [2013] stressing the low absolute risk of liver injury from the fluoroquinolones [4-9 per 100,000 exposures]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to levofloxacin or other fluoroquinolones).
Naveen KN, Pai VV, Rai V, Athanikar SB. (2013). Retrospective analysis of Steven Johnson syndrome and toxic epidermal necrolysis over a period of 5 years from northern Karnataka, India. Indian J Pharmacol. (Among 22 patients seen at a single referral hospital in India between 2002-2007 with Stevens Johnson syndrome or toxic epidermal necrolysis, 11 were due to anticonvulsants and 7 to antibiotics, including 1 attributed to levofloxacin).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 29 [5.1%] attributed to quinolones).
Harr T, French LE. (2012). Stevens-Johnson syndrome and toxic epidermal necrolysis. Chem Immunol Allergy. (Review of the clinical features, epidemiology, genetics and pathogenesis of SJS and TEN).
Patel TK, Barvaliya MJ, Sharma D, Tripathi C. (2013). A systematic review of the drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Indian population. Indian J Dermatol Venereol Leprol. (Systematic review of 10 case series of SJS/TEN from India identified 352 cases, among which 342 implicated a medication with most common being antimicrobials [37%], anticonvulsants [16%] and NSAIDs [16%]; fluoroquinolones accounted for 33 cases [10%], 4 of which were due to ciprofloxacin, 1 ofloxacin and 1 levofloxacin).
Pubill-Fondevila N, Bielsa S, Porcel JM. (2013). Med Clin (Barc). (36 year old man with pneumonia and brochiectasis developed jaundice 3 days after starting levofloxacin [bilirubin 11.7 mg/dL, ALT 186 U/L, Alk P 198 U/L] resolving within 3 weeks of stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one due to trovafloxacin [acute liver failure], but none attributed to ciprofloxacin or other fluoroquinolones).
Alshammari TM, Larrat EP, Morrill HJ, Caffrey AR, Quilliam BJ, LaPlante KL. (2014). Risk of hepatotoxicity associated with fluoroquinolones: a national case-control safety study. Am J Health Syst Pharm. (Retrospective analysis of Veterans Affairs patients receiving a fluoroquinolone [n=7862] found a higher relative risk of developing acute liver injury after receipt of ciprofloxacin compared to matched controls [adjusted odds ratio: OR=1.29], but not after receipt of levofloxacin [OR=1.16) or moxifloxacin [OR=0.98]).
Lontos S, Shelton E, Angus PW, Vaughan R, Roberts SK, Gordon A, Gow PJ. (2014). A randomized controlled study of trimethoprim-sulfamethoxazole versus norfloxacin for the prevention of infection in cirrhotic patients. J Dig Dis. (Among 80 patients with advanced cirrhosis given oral prophylaxis with daily trimethoprim-sulfamethoxazole or norfloxacin, infection rates were similar in the two groups as were rates of death and liver transplantation as well as adverse event rates; not instances of drug-induced liver injury).
Levine C, Trivedi A, Thung SN, Perumalswami PV. (2014). Severe ductopenia and cholestasis from levofloxacin drug-induced liver injury: a case report and review. Semin Liver Dis. (67 year old woman with streptococcal infection developed jaundice 8 weeks after starting levofloxacin [bilirubin 6.3 mg/dL, ALT 614 U/L, Alk P 483 U/L] with prolonged jaundice and biopsy showing bile duct loss).
García Juárez I, Miquel R, Forns X, Bruguera M. (2014). Gastroenterol Hepatol. (59 year old woman had raised ALT [389 U/L] and eosinophilia [16%] 7 days after starting levofloxacin that resolved on stopping and recurred on restarting with autoimmune features on liver biopsy [ALT 355 U/L, Alk P 345 U/L, bilirubin 0.4 mg/dL] that responded to immunosuppression which was ultimately discontinued without recurrence).
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. (2014). Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy. (In a nested case control analysis of a health care network database of persons between 2001 and 2009, 8 selected antibiotics were assessed for association with risk of hospitalization for liver injury, adjusted relative risks being significantly elevated for levofloxacin [3.2], moxifloxacin [2.3], doxycycline [2.5], amoxicillin/clavulanate [2.5] and amoxicillin [2.3], but not for clarithromycin [1.8], telithromycin [1.7] or cefuroxime [0.9]).
Charfi O, Lakhoua G, Sahnoun R, Badri T, Daghfous R, El Aidli S, Kastalli S, et al. (2015). DRESS syndrome following levofloxacin exposure with positive patch-test. Therapie. (26 year old man developed fever, rash and lymphadenopathy 5 days after starting levofloxacin and metronidazole [bilirubin not given, ALT 211 U/L, GGT 90 U/L], resolving within 1-2 weeks of stopping, with positive patch test to levofloxacin but also positive IgM anti-EBV).
Gulen M, Ay MO, Avci A, Acikalin A, Icme F. (2015). Levofloxacin-induced hepatotoxicity and death. Am J Ther. (53 year old woman developed rash within a day of receiving levofloxacin followed by jaundice and confusion [bilirubin 14.6 mg/dL, ALT 1222 U/L, Alk P not given, INR 6.5], with metabolic acidosis followed by cardiac arrest and death).
Goldberg DS, Forde KA, Carbonari DM, Lewis JD, Leidl KB, Reddy KR, Haynes K, et al. (2015). Population-representative incidence of drug-induced acute liver failure based on an analysis of an integrated health care system. Gastroenterology. (Analysis of Kaiser Permanente health care database from 2004 to 2011 identified 62 patients with suspected acute liver failure, 32 [52%] of whom had a presumed drug etiology, the most common being acetaminophen [18: 56%] and various herbal products [5: 16%], with single instances attributed to imatinib, simvastatin, leflunomide, isoniazid and valproate, but none to ciprofloxacin or other fluoroquinolones).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 38 cases [4%] were attributed to fluoroquinolones, including 16 due to ciprofloxacin [the 8th most common prescription drug cause], 13 due to levofloxacin and 8 to moxifloxacin).
Elliott TR, Symes T, Kannourakis G, Angus P. (2016). Resolution of norfloxacin-induced acute liver failure after N-acetylcysteine therapy: further support for the use of NAC in drug-induced ALF?. BMJ Case Rep. (77 year old woman developed jaundice 2 weeks after a 3-day course of norfloxacin [bilirubin 8.5 mg/dL, ALT 248 U/L, Alk P 256 U/L] with progression to hepatic failure [INR 2.7], but dramatic clinical improvement after a 2 day infusion of N-acetylcysteine, liver tests normalizing 3 months later).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, Ghabril MS, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss of whom 94% developed evidence of chronic liver injury suggestive of vanishing bile duct syndrome, 2 of which were due to fluoroquinolones, 1 to moxifloxacin and 1 levofloxacin).
Yim HJ, Suh SJ, Jung YK, Yim SY, Seo YS, Lee YR, Park SY, Jang JY, Kim YS, Kim HS, Kim BI, Um SH. (2018). Daily norfloxacin vs. weekly ciprofloxacin to prevent spontaneous bacterial peritonitis: a randomized controlled trial. Am J Gastroenterol. (Among 124 patients with cirrhosis and ascites given prophylaxis with daily norfloxacin [400 mg] or weekly oral ciprofloxacin [750 mg], subsequent rates of bacterial peritonitis were similar [7% vs 5%] as were rates of liver transplantation and death).
Moreau R, Elkrief L, Bureau C, Perarnau JM, Thévenot T, Saliba F, Louvet A, et al., NORFLOCIR Trial Investigators. (2018). Effects of long-term norfloxacin therapy in patients with advanced cirrhosis. Gastroenterology. (Among 291 patients with advanced cirrhosis treated for 6 to 12 months with daily oral norfloxacin or placebo, 6 month mortality rate was less with norfloxacin [15% vs 19%] as were gram-negative bacterial infections and no norfloxacin-related severe adverse events were identified).
Schloss M, Becak D, Tosto ST, Velayati A. (2018). A case of levoﬂoxacin-induced hepatotoxicity. Am J Case Rep. (30 year old man with sepsis was treated with clindamycin followed by levofloxacin after which he had ALT elevations [ALT rising from 24 to 1110 U/L, Alk P 175 to 269 U/L, bilirubin normal], improving within days of stopping).
(2018). Comparison table: some systemic fluoroquinolones. Med Lett Drugs Ther. (Table comparing 4 fluoroquinolones [cipro-, levo-, dela- and moxifloxacin] mentions that ALT and AST elevations are a class adverse event).
Mavros MN, Theochari NA, Kyriakidou M, Economopoulos KP, Sava JA, Falagas ME. (2019). Fluoroquinolone-based versus β-lactam-based regimens for complicated intra-abdominal infections: a meta-analysis of randomised controlled trials. Int J Antimicrob Agents. (Systematic review of controlled trials of fluoroquinolones versus βlactam-based antibiotic regimens found similar rates of efficacy and adverse events, no discussion of ALT elevations or liver related toxicities).
Kuula LSM, Viljemaa KM, Backman JT, Blom M. (2019). Fluoroquinolone-related adverse events resulting in health service use and costs: A systematic review. PLoS One. (Systematic review of observational studies on safety of fluoroquinolones concluded that due to lack of published literature, health service and costs could not be evaluated).

## OTHER REFERENCE LINKS

1 Recent References on Levofloxacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=levofloxacin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Levofloxacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=levofloxacin)